# Nifedipine

## OVERVIEW

### Introduction

Nifedipine is a first generation calcium channel blocker used to treat hypertension and angina pectoris. Nifedipine therapy is associated with a low rate of serum enzyme elevations and has been linked to several instances of clinically apparent acute liver injury.

### Background

Nifedipine (nye fed' i peen) belongs to the dihydropyridine class of calcium channel blockers (first in its class and similar to amlodipine, felodipine and nicardipine) and is used for the treatment of hypertension and angina pectoris. Like other calcium channel blockers, nifedipine acts by inhibiting the transmembrane influx of calcium into cardiac and smooth muscle cells during depolarization. The inhibition of calcium influx causes arterial vasodilation and decreases cardiac work and oxygen consumption. Nifedipine was approved in the United States in 1982 and currently several million prescriptions are filled yearly. Current indications include hypertension and chronic stable and Prinzmetal's variant angina pectoris. It is also used off label to treat Raynaud phenomenon. Nifedipine is available in capsules of 10 and 20 mg and as extended release tablets of 30, 60 and 90 mg in several generic formulations as well as under brand names including Procardia, Adala, Afeditab, Nifediac, and Nifedical. The typical dose in adults is 30 to 60 mg daily, usually starting with lower doses. Nifedipine is generally well tolerated and side effects are largely due to its vasodilating activities and can include dizziness, flushing, headache, fatigue, nausea, diarrhea, palpitations, bradycardia, peripheral edema and skin rash.

### Hepatotoxicity

Mild and transient elevations in serum aminotransferase levels may occur during nifedipine therapy, but often resolve even with continuation of therapy. Clinically apparent acute liver injury with jaundice due to nifedipine is rare and described only in isolated case reports. The time to onset of injury is typically 1 to 2 months and the pattern of serum enzyme elevations is usually hepatocellular or mixed. Rash, arthralgias, fever and eosinophilia can occur, but are not prominent. Chronic aminotransferase elevations during continued therapy with nifedipine have been described sometimes with histological features of alcoholic liver disease (steatosis and Mallory bodies), but chronic liver injury after withdrawal has not. Nifedipine has not been implicated in cases of vanishing bile duct syndrome or acute liver failure in the published literature.

Likelihood score: B (likely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of nifedipine hepatotoxicity is not known, but is likely to be due to production of a toxic or immunogenic intermediate during its metabolism by the liver.

### Outcome and Management

The severity of liver injury from nifedipine ranges from mild and transient serum enzyme elevations to self-limited jaundice to an alcoholic hepatitis-like syndrome. Complete recovery is expected after stopping the drug and recovery is usually rapid (3 to 8 weeks). There is little information on cross sensitivity to liver injury among the various calcium channel blockers, but related medications should be started with caution in patients with clinically apparent liver injury from nifedipine.

Drug Class: Cardiovascular Agents, Calcium Channel Blockers

Other Drugs in the Subclass, Calcium Channel Blockers: Amlodipine, Diltiazem, Felodipine, Isradipine, Nicardipine, Nimodipine, Nisoldipine, Verapamil

## CASE REPORT

### Case 1. Acute hepatitis-like syndrome attributed to amlopidine.

[Modified from: Basile C, Mascia E. Dihydropyridine calcium channel blockers: a rare and reversible cause of hepatotoxicity with cholestasis in a CAPD patient. Nephrol Dial Transplant 1999; 14: 2776-7. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/10534534)]

A 76 year old man with diabetes and end stage renal disease developed jaundice while on long term nifedipine therapy (60 mg daily for ~3 years) for hypertension. He was taking insulin, but no other medications. He had no risk factors for viral hepatitis and did not drink alcohol. Serum bilirubin was 2.5 mg/dL and rose over the next few months to 6.2 mg/dL. Tests for acute hepatitis A, B and C were negative and abdominal ultrasonography showed a normal liver and gallbladder. Nifedipine was stopped and he recovered rapidly. Several months later, amlodipine was started (10 mg daily) and within 6 weeks, he developed jaundice and a cholestatic pattern of serum enzyme elevations. Once amlodipine was stopped, liver tests improved and were normal three weeks later.

#### Key Points

Medication: | Nifedipine (60 mg daily) and then amlodipine (10 mg daily)
Pattern: | Cholestatic (R=0.3 and 0.8 during recurrence)
Severity: | 2+ (jaundiced, but not hospitalized for liver injury)
Latency: | 3 years for nifedipine, 2 months for amlodipine
Recovery: | 3 to 4 weeks
Other medications: | Insulin

#### Laboratory Values

Date | Duration Therapy | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Long term therapy with nifedipine (60 mg daily)
May 12, 1998 | 3 years | | 13 | 144 | 0.3
Sep 9, 1998 | | | 47 | 783 | 0.5
Dec 9, 1998 | | | 40 | 955 | 2.5
Jan 11, 1999 | 3.5 years | 0 | 79 | ... | 6.2
Nifepidine stopped January 11, 1999
Jan 16, 1999 | | 1 week | 46 | 531 | 4.0
Jan 23, 1999 | | 2 weeks | 45 | 419 | 1.8
Feb 11, 1999 | | 4 weeks | 17 | 185 | 0.9
Amlodipine (10 mg daily) started in late March, 1999
Apr 10, 1999 | 2 weeks | | 43 | 398 | 0.6
May 5, 1999 | 6 weeks | 0 | 74 | 398 | 6.3
Amlodipine stopped May 7, 1999
May 11, 1999 | | 4 days | 70 | 399 | 5.4
May 13, 1999 | | 6 days | 54 | 314 | 4.1
May 28, 1999 | | 3 weeks | 19 | 181 | 1.3
Normal Values | | | <55 | <250 | <1.2

#### Comment

One of the few reports of acute liver injury with jaundice attributed to calcium channel blockers. The patient initially developed a cholestatic hepatitis while on long term nifepidine therapy. Liver tests because steadily worse and nifepidine was ultimately withdrawn, whereupon liver tests fell to normal within 4 weeks. There was a recurrence of liver injury within 2 to 6 weeks of restarting another calcium channel blocker, with a similar pattern of liver test abnormalities and a similar rapid improvement upon stopping. Both nifedipine and amlodipine are dihydropyridines, but there structures are dissimilar.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Nifedipine – Generic, Adalat®, Procardia®

DRUG CLASS

Cardiovascular Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=nifedipine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Nifedipine | 21829-25-4 | C17-H18-N2-O6 | Nifedipine chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 11 January 2017

Zimmerman HJ. Calcium channel blockers. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 646-7. (Expert review of hepatotoxicity published in 1999; among calcium channel blockers, diltiazem, nifedipine, bepridil and verapamil have been incriminated in instances of hepatic injury).
De Marzio DH, Navarro VJ. Calcium channel blockers. Hepatotoxicity of cardiovascular and antidiabetic drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 524. (Review of hepatotoxicity of calcium channel blockers mentions that diliazem, nefidipine and verapamil have been implicated in causing cholestatic liver injury in a small number of patients).
Michel T, Hoffman BB. Calcium channel antagonists. Treatment of myocardial ischemia. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 755-60. (Textbook of pharmacology and therapeutics).
Rotmensch HH, Roth A, Liron M, Rubinstein A, Gefel A, Livni E. Lymphocyte sensitization in nifedipine-induced hepatitis. Br Med J 1980; 281; 976-7. (69 year old man developed fever and jaundice 10 days after starting nifedipine [bilirubin 3.0 mg/dL, AST 56 U/L, Alk P 420 U/L, ESR 95 mm/hr], with rapid resolution and recurrence of fever and Alk P elevations after rechallenge with a single dose). 7000285
Davidson AR. Lymphocyte sensitization to nifedipine-induced hepatitis. Br Med J 1980; 281: 1354. (Letter in response to Rotmensch [1980] with a similar case: 59 year old man developed fatigue 2 weeks after starting nifedipine [bilirubin 3.0 mg/dL, ALT 49 U/L, Alk P 1.5 times ULN], resolving rapidly upon stopping). 7437797
Abramson M, Littlejohn GO. Hepatic reactions to nifedipine. Med J Aust 1985; 142: 47-8. (Two cases: 65 year old man developed jaundice 6 weeks after starting nifedipine [bilirubin 1.8 mg/dL, ALT 1220 U/L, Alk P 1094 U/L], resolving within 1 month and later tolerating verapamil; 72 year old man developed fever and arthralgias 6 weeks after starting verapamil [bilirubin normal; ALT 100 U.L, Alk P 457 U/L], resolving in a few weeks). 3965874
Welch HG, Lazar B, Gresser J, McMahon BJ. Nifedipine-induced hepatitis. Alaska Med 1986; 28:11-2. (50 year old woman with myocardial ischemia developed AST elevations [31 rising to 361 U/L] within 4 days of starting nefidipine, with no change in bilirubin [1.0 mg/dL] and rapid resolution when it was stopped). 3717520
Kiire CF, Rutherford D. Nifedipine-associated jaundice: a second case. East Afr Med J 1986; 63: 560-1. (75 year old man developed jaundice and abdominal pain 2 weeks after starting nifedipine [bilirubin 3.5 mg/dL, AST 53 U/L, Alk P 139 U/L], resolving within 2 months of stopping). 3792245
Richter WO, Schwandt P. Serious side effects of nifedipine. Arch Intern Med 1987; 147: 1852. (69 year old woman developed marked Alk P elevations [943 U/L] with normal bilirubin [1.5 mg/dL], with no change after stopping prazosin and allopurinol, but prompt decrease after stopping nifedipine and recurrence on inadvertent rechallenge [Alk P 529 U/L]). 3662717
Shaw DR, Misan GM, Johnson RD. Nifedipine hepatitis. Aust N Z J Med 1987; 17: 447-8. (80 year old woman developed nausea and abdominal pain 4 days after starting nifedipine and having an episode of shock [bilirubin 2.0 mg/dL, AST 1065 U/L, LDH 1190 U/L, Alk P 352 U/L], resolving within 8 weeks). 3435325
Biour M, Grange JD, Barbare JC, et al. [Hepatic involvement due to nifedipine. Description of a case and review of the literature] Therapie 1987; 42: 301-3 [French]. (60 year old man developed jaundice 10 days after starting nifedipine [bilirubin 16.1 mg/dL, ALT 36 times ULN, Alk P 2.3 times ULN], resolving within one month of stopping). 3660324
Babany G, Uzzan F, Larrey D, et al. Alcohol-like liver lesions induced by nifedipine. J Hepatol 1989; 9: 252-5. (78 year old woman taking nifedipine developed mild elevations of Alk P [1.5 times ULN] and GGT [5.3 times ULN] and underwent liver biopsy that showed steatohepatitis and Mallory bodies, and had ascites 6 months later despite normal enzymes; repeat biopsy showed fibrosis and fat without Mallory bodies; no follow up after stopping nefidine was given). 2809167
Sawaya GF, Robertson PA. Hepatotoxicity with the administration of nifedipine for treatment of preterm labor. Am J Obstet Gynecol 1992; 167: 512-3. (25 year old pregnant woman developed early uterine contractions and was treated with terbutaline and nifedipine whereupon ALT rose to as high as 845 U/L with no symptoms or jaundice, falling to normal 2 weeks after delivery and stopping nifedipine). 1497061
Basile C, Mascia E. Dihydropyridine calcium channel blockers: a rare and reversible cause of hepatotoxicity with cholestasis in a CAPD patient. Nephrol Dial Transplant 1999; 14: 2776-7. (76 year old man developed jaundice 3 years after starting nifedipine [bilirubin 6.2 mg/dL, ALT 79 U/L, Alk P 955 U/L], resolving within 1 month of stopping and recurring within 6 weeks of starting amlodipine [bilirubin 6.3 mg/dL, ALT 74 U/L, Alk P 398 U/L] resolving in 3 weeks: Case 1). 10534534
Brown MJ, Palmer CR, Castaigne A, de Leeuw PW, Mancia G, Rosenthal T, Ruilope LM. Morbidity and mortality in patients randomised to double-blind treatment with a long-acting calcium-channel blocker or diuretic in the International Nifedipine GITS study: Intervention as a Goal in Hypertension Treatment (INSIGHT). Lancet 2000; 356: 366-72. (Randomized clinical trial of nifedipine versus diuretics for an average of 3 years in 6321 patients reported similar outcomes and no differences in adverse events; liver toxicity not mentioned). 10972368
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, but none were attributed to calcium channel blockers). 15390328
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-101. (Summary of 25 years of adverse drug reaction reporting in Sweden identified 103 cases of drug induced acute liver failure; only one case was possibly linked to a calcium channel blocker: felodipine). 16165719
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, calcium channel blockers were implicated as a sole agent in 2 cases [1 amlodipine, 1 verapamil] and as one of several agents in 2 cases [both amlodipine]). 18955056
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were linked to calcium channel blockers). 20949552
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 114: 1419-25. Pub (https://www.ncbi.nlm.nih.gov/pubmed/23419359) Med Citation (https://www.ncbi.nlm.nih.gov/pubmed/23419359) (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but no cases were attributed to calcium channel blockers).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases; one case was attributed to verapamil, but none were linked to diltiazem or other calcium channel blockers). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 39 [4%] were due to antihypertensive agents including 4 due to calcium channel blockers [amlodipine in 1 and verapamil in 3 instances], but none to diltiazem). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Nifedipine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=nifedipine/AE+AND+Human%5BMH%5D+AND+(drug-induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222000/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Nifedipine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=nifedipine)